# Osilodrostat

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Osilodrostat is an inhibitor of cortisol synthesis that is used in the treatment of Cushing disease not controlled by standard therapy. Osilodrostat therapy has not been linked to serum aminotransferase elevations during therapy or with instances of clinically apparent liver injury.

### Background

Osilodrostat (oh sil” oh droe’ stat) is a small molecule inhibitor of cortisol synthesis used for patients with Cushing disease not eligible for or not cured by surgical resection. Osilodrostat lowers serum levels of cortisol and can decrease symptoms and signs of Cushing disease. In preregistration trials, osilodrostat reached the designated response rate in 86% of treated subjects. An important part of use of osilodrostat was the careful monitoring of cortisol and titration of the dose so as not to precipitate adrenal failure. Osilodrostat was approved in the United States in 2020 as therapy of patients with Cushing disease for whom surgery is not an option or has not been curative. Osilodrostat is available in tablets of 1, 5, and 10 mg under the brand name Isturisa. The recommended starting dosage is 2 mg twice daily, with subsequent careful titration of the dose in 1 to 2 mg increments at two-week intervals to achieve adequate suppression of serum cortisol levels. In registration trials that employed careful titration and monitoring, the most frequent adverse events were adrenal insufficiency (43%), fatigue (39%), nausea (37%), headache (31%), edema (21%), and lesser rates of arthralgia, rash, back pain, diarrhea, and dizziness. Uncommon but potentially serious adverse events included prolongation of the QTc interval, acute hypercortisolism, and adrenal failure. Monitoring of the electrocardiogram, blood pressure, serum cortisol and potassium levels, and signs of adrenal failure and hormonal changes (hirsutism, weight loss, worsening hypotension) is important. Osilodrostat should be prescribed only by health care personnel with knowledge and experience in managing hyper- and hypo-cortisolism.

### Hepatotoxicity

In preregistration trials, mild, transient serum aminotransferase elevations occurred in 37 of 137 (27%) patients receiving osilodrostat for Cushing disease, but in only 8 (6%) patients were values above 3 times the upper limit of normal (ULN), and only 1 was above 5 times ULN (<1%). Furthermore, bilirubin levels remained normal and no patient developed symptomatic acute liver injury. In most instances, other causes for the liver test abnormalities were present including preexisting nonalcoholic fatty liver disease, gallstone disease, and hepatic metastases from the adrenal tumor. No patient required discontinuation of therapy for liver test abnormalities. Since its licensure and its more widescale clinical use, there have been no reports of acute liver injury attributed to osilodrostat.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of liver test abnormalities during osilodrostat therapy of refractory Cushing disease are often unrelated to the drug and are attributable to comorbidities of patients with hypercortisolism, such as fatty liver disease, gallstone disease, or malignancy.

### Outcome and Management

The product label for osilodrostat does not recommend monitoring of routine liver tests during therapy with osilodrostat, but testing patients before starting therapy is appropriate because of the frequency of comorbidities including liver disease in patients with hypercortisolism. Rise in serum aminotransferase levels during therapy should trigger evaluation for other possible causes. Persistence of unexplained ALT levels above 3 times the ULN or appearance of symptoms of liver injury or jaundice should lead to at least temporary discontinuation and more careful monitoring.

Drug Class: Endocrine Disease Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Osilodrostat – Isturisa®

DRUG CLASS

Endocrine Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Osilodrostat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Osilodrostat | 928134-65-0 | C13-H10-FN3

## BIBLIOGRAPHY

References updated: 14 May 2024

Abbreviations: ULN, upper limit of the normal range.

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm. All other references have not been fully reviewed and annotated.]

FDA. Integrated Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212801Orig1s000MedR.pdf (FDA summary data on the safety and efficacy of osilodrostat, submitted in support of the application for approval as therapy of Cushing disease, mentions that 34% of 137 treated subjects in the registration trial had an ALT or AST elevation, but they were mostly mild, frequently attributable to co-existing conditions, only 2.9% were above 3 times the upper limit or normal (ULN), and no patient developed enzyme elevations with jaundice or symptoms).
Bertagna X, Pivonello R, Fleseriu M, Zhang Y, Robinson P, Taylor A, Watson CE, et al. LCI699, a potent 11β-hydroxylase inhibitor, normalizes urinary cortisol in patients with Cushing's disease: results from a multicenter, proof-of-concept study. J Clin Endocrinol Metab. 2014;99:1375-83.24423285
Fleseriu M, Pivonello R, Young J, Hamrahian AH, Molitch ME, Shimizu C, Tanaka T, et al. Osilodrostat, a potent oral 11β-hydroxylase inhibitor: 22-week, prospective, Phase II study in Cushing's disease. Pituitary. 2016;19:138-48.26542280
Duggan S. Osilodrostat: first approval. Drugs. 2020;80:495-500.32141023
Pivonello R, Fleseriu M, Newell-Price J, Bertagna X, Findling J, Shimatsu A, Gu F, et al; LINC 3 investigators. Efficacy and safety of osilodrostat in patients with Cushing's disease (LINC 3): a multicentre phase III study with a double-blind, randomised withdrawal phase. Lancet Diabetes Endocrinol. 2020;8:748-761.32730798
Osilodrostat (Isturisa) for Cushing's disease. Med Lett Drugs Ther. 2021;63(1617):21-23.33647005
Chabre O, Muller M, Cristante J, Cracowski JL, Gay E. Osilodrostat for the treatment of Cushing's disease: efficacy, stability, and persistence. Lancet Diabetes Endocrinol. 2022;10:384-385.35597254
Gadelha M, Bex M, Feelders RA, Heaney AP, Auchus RJ, Gilis-Januszewska A, Witek P, et al. Randomized trial of osilodrostat for the treatment of Cushing disease. J Clin Endocrinol Metab. 2022;107:e2882-e2895.35325149
Fleseriu M, Newell-Price J, Pivonello R, Shimatsu A, Auchus RJ, Scaroni C, Belaya Z, et al. Long-term outcomes of osilodrostat in Cushing's disease: LINC 3 study extension. Eur J Endocrinol. 2022;187:531-541.35980235
Fleseriu M, Biller BMK, Bertherat J, Young J, Hatipoglu B, Arnaldi G, O'Connell P, et al. Long-term efficacy and safety of osilodrostat in Cushing's disease: final results from a Phase II study with an optional extension phase (LINC 2). Pituitary. 2022;25:959-970.36219274
Gadelha M, Snyder PJ, Witek P, Bex M, Belaya Z, Turcu AF, Feelders RA, et al. Long-term efficacy and safety of osilodrostat in patients with Cushing's disease: results from the LINC 4 study extension. Front Endocrinol (Lausanne). 2023;14:1236465.37680892
Ferriere A, Salenave S, Puerto M, Young J, Tabarin A. Prolonged adrenal insufficiency following discontinuation of osilodrostat treatment for intense hypercortisolism. Eur J Endocrinol. 2024;190:L1-L3.38123490

## OTHER REFERENCE LINKS

1. Recent References on Osilodrostat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Osilodrostat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Osilodrostat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Osilodrostat)